# Bland Cholestasis

Description. The course of illness is marked by prominent and typically prolonged jaundice and cholestasis with minimal serum enzyme elevations or evidence of hepatocellular necrosis.

Latency to Onset. The time to onset of bland cholestasis is typically, 4 to 24 weeks after starting the medication.

Symptoms. An insidious onset of itching followed by dark urine and jaundice. There may be weakness and fatigue early in the course, but patients generally feel rather well despite deep jaundice. Pruritus may be particularly troublesome. Recovery is delayed even after stopping the implicated agent, and jaundice may last several months.

Serum Enzyme Elevations. Alkaline phosphatase and aminotransferase levels are only modestly elevated, particularly in relationship to the degree of jaundice. ALT levels are usually <200 U/L (<5 times ULN), alkaline phosphatase <230 U/L (<2 times elevated). Both may be normal.

Drugs. Typical causative agents of bland cholestasis are the androgenic steroids, this pattern being almost pathognomic. Bland cholestasis can also occur with estrogen therapy, particularly in high doses and in women with a history of cholestasis of pregnancy. Azathioprine, mercaptopurine and other antimetabolites can occasionally cause acute liver injury that resembles bland cholestasis.

Differential Diagnosis. Bland cholestasis is almost pathognomic for anabolic steroid induced jaundice in men and estrogen induced cholestasis in women. It resembles the idiopathic cholestasis of pregnancy. A similar biochemical pattern of minimal serum enzyme elevations despite marked jaundice can also occur late in the course of biliary obstruction and late during a case of cholestatic or mixed drug induced hepatitis.

Criteria for Definition. Elements important in diagnosis of bland cholestasis due to medications include:

1 Minimal elevations in ALT (<200 U/L or <5 times ULN) and alkaline phosphatase (<230 U/L or <2 times ULN)
2 Latency of 4 to 24 weeks
3 Insidious onset of symptoms of pruritus and jaundice
4 Bilirubin >2.5 mg/dL
5 Slow recovery of more than 4 weeks
6 Exposure to an agent known to cause bland cholestasis (anabolic steroids, estrogens)
7 If liver biopsy is obtained, changes of intrahepatic cholestasis with minimal inflammation or hepatocellular necrosis.

While bland cholestasis is actually a histological diagnosis, this pattern can be assumed to be present in the setting of typical clinical and serum biochemical findings. The latency to onset may be greater than 24 weeks, particularly if the agent is used intermittently or if a dose escalation occurs. Bland cholestasis can present with ALT levels of 200 to 400 U/L (5 to 10 times ULN) or alkaline phosphatase to 230 to 345 IU/L (2 to 3 times ULN) at the very onset, but they generally fall rapidly to more modest levels.

## Representative Cases

### Case 1. Cholestasis due to androgenic steroid use.

[Modified from: Singh C, Bishop P, Wilson R. Extreme hyperbilirubinemia associated with the use of anabolic steroids, health/nutritional supplements and ethanol: response to ursodeoxycholic acid treatment. Am J Gastroenterol 1996; 91: 783-5. PubMed Citation]

A 24 year old male body builder developed pruritus and jaundice having taken various anabolic steroids for one and a half years. He was also taking several herbal products and dietary supplements including Ma Huang (6% ephedrine), carnitine and chromium. He drank alcohol, estimating his average intake as one case of beer per day for the last year. When he developed dark urine and jaundice, he stopped all medications and his alcohol intake promptly. Despite this he remained jaundiced for a month and had worsening nausea and weight loss and eventually sought medical care. He had no history of liver disease or risk factors for viral hepatitis and took no other medications. On examination, he was muscular and physically fit but deeply jaundiced. He had an enlarged liver but no rash, fever or splenomegaly. Laboratory testing showed a total serum bilirubin of 53 mg/dL, but only modest elevations in serum aminotransferase and a normal alkaline phosphatase level (Table). His prothrombin time was normal. Tests for hepatitis A, B and C were negative. Abdominal ultrasound showed no evidence of biliary obstruction. Liver biopsy was not done. He was treated symptomatically for pruritus with antihistamines, cholestyramine and ursodiol. His jaundice gradually improved and pruritus waned. Six months after the onset of jaundice, he was asymptomatic, had regained most of his weight loss (40 pounds), serum bilirubin was 1.5 mg/dL and serum enzymes were normal.

#### Key Points

Medication: | Anabolic steroids (nandrolone, stanozolol)
Pattern: | Bland cholestasis
Severity: | 3+ (jaundice, hospitalization)
Latency: | 16 weeks
Recovery: | 0.6 months
Other medications: | Various herbal products and dietary supplements

#### Laboratory Values

Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Anabolic steroid use for ~1.5 years
6 weeks | 237 | 129 | 21
8 weeks | 90 | 121 | 53
10 weeks | 203 | 91 | 51 | Ursodiol started
12 weeks | 119 | 81 | 22
14 weeks | 116 | 67 | 8
4 months | 58 | 50 | 4
5 months | 33 | 75 | 1.5 | Asymptomatic
Normal Values | <56 | <139 | <1.2

#### Comment

A very typical case of severe cholestasis due to anabolic steroid use. Because the steroids were being used without medical supervision, the dose and actual duration of use of each preparation was unclear, but cholestasis usually arises within 4 to 12 weeks of starting a C-17 alkylated androgenic steroid. The jaundice can be severe and prolonged and accompanied by severe pruritus and marked weight loss. The serum enzymes are typically minimally elevated except for a short period immediately after stopping therapy. The pattern of enzyme elevations can be hepatocellular, cholestatic or mixed. Liver biopsy shows a "bland" cholestasis with minimal inflammation and hepatocellular necrosis. Ma Huang has also been implicated in cases of drug induced liver injury, but is associated with an acute hepatocellular pattern of injury.

### Case 2. Cholestasis due to birth control pills.

[Modified from: Boake WC, Schade SG, Morrissey JF, Schaffner F. Intrahepatic cholestatic jaundice of pregnancy followed by Enovid-induced cholestatic jaundice. Ann Intern Med 1965; 63: 302-8. PubMed Citation]

A 28 year old woman developed pruritus within 4 days of starting oral contraceptives and stopped them after a week. One week later (14 days after starting), she had darkening of the urine and was found to the jaundiced 4 weeks later. She was taking no other medications and had no risk factors for viral hepatitis. Important in her past medical history were episodes of jaundice and pruritus during two pregnancies. The jaundice arose during the fifth month of her second and the sixth week of her third pregnancies, with peak bilirubin values of 3.5 and 3.8 mg/dL and prominence of pruritus. The cause of jaundice during her pregnancies was not identified despite extensive evaluation including laparotomy and cholecystectomy (the gallbladder was normal without stones). Thereafter, she was well until she started birth control pills. On examination, she was jaundiced but had no fever or rash. Serum bilirubin was 4.5 mg/dL, ALT 352 U/L and alkaline phosphatase 24 King Armstrong units (~2 times upper limit of normal) (Table). A liver biopsy showed intrahepatic cholestasis with minimal inflammation. Upon stopping the contraceptive pills, serum laboratory tests improved and jaundice cleared within 2 weeks. However, she continued to have pruritus for 3 months after stopping the medication. Ultimately, all symptoms and itching resolved and laboratory tests except for alkaline phosphatase were normal 6 months later.

#### Key Points

Medication: | Enovid (once daily)
Pattern: | Bland cholestasis
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 days to symptoms, 2 weeks to jaundice
Recovery: | Jaundice resolved in 2 weeks, symptoms in 3 months
Other medications: | None

#### Laboratory Values

Time After Stopping | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| | Enovid once daily for 7 days
6 weeks | 5 weeks | 352 | 24 | 4.2 | Direct bilirubin 2.4
7 weeks | 6 weeks | 356 | 25 | 5.5 | Liver biopsy
3 months | 11 weeks | 58 | 27 | 1.2
8 months | 30 weeks | 38 | 20 | 0.8
Normal Values | | <40 | <13 | <1.2

#### Comment

A woman with a history of idiopathic cholestasis of pregnancy developed pruritus a few days after starting birth control pills and dark urine followed by jaundice several weeks later. The ratio of ALT to alkaline phosphatase elevations suggested that the injury was "mixed," but the liver biopsy showed bland intrahepatic cholestasis with little hepatocyte necrosis or inflammation and the symptoms were decidedly cholestatic, with a prominence of pruritus that only slowly resolved.

### Case 3. Prolonged cholestasis due to birth control pills.

[Modified from: Lieberman DA, Keefe LB, Stenzel P. Severe and prolonged oral contraceptive jaundice. J Clin Gastroenterol 1984; 6: 145-8. PubMed Citation]

A 22 year old woman developed jaundice and pruritus after a single 28 day cycle of oral contraceptives (Lo-Ovral: norgestrel 0.3 mg and ethinyl estradiol 0.03 mg), which were started shortly after a first trimester abortion. Over the next several months, she developed worsening pruritus, anorexia, nausea, fatigue and weight loss. She had no previous history of liver disease or risk factors for viral hepatitis. Her only medications were birth control pills and rarely acetaminophen for pain. Examination showed marked jaundice and multiple excoriations. The liver was enlarged and somewhat tender to palpation. Laboratory results showed bilirubin of 7.0 mg/dL, ALT 80 U/L and Alk P 170 U/L (Table). Because of persistent jaundice, she underwent endoscopic retrograde cholangiopancreatography which was normal. A liver biopsy showed intrahepatic cholestasis with minimal inflammation and bile duct proliferation. She eventually began to improve and all laboratory values were normal or near normal 6 months later.

#### Key Points

Medication: | Lo-Ovral (once daily for one cycle)
Pattern: | Bland cholestasis
Severity: | 3+ (jaundice, prolonged)
Latency: | 1 months
Recovery: | 6 months
Other medications: | Occasional acetaminophen

#### Laboratory Values

Time After Stopping | | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
1 month | 0 | 90 | 165 | 7.0 | | Pruritus and jaundice
| 2 weeks | 80 | 250 | 11.0
2 months | 4 weeks | 105 | 290 | 15.3
| 6 weeks | 110 | 405 | 17.5 | | ERCP and liver biopsy
3 months | 8 weeks | 130 | 380 | 18.2
| 10 weeks | 145 | 390 | 19.5
4 months | 12 weeks | 155 | 490 | 17.5
14 weeks | 190 | 556 | 13.6
5 months | 4 months | 219 | 360 | 5.8
6 months | 5 months | 60 | 200 | 1.7
7 months | 6 months | 35 | 125 | 0.5
Normal Values | | <40 | <115 | <1.2

* Values and dates estimated from Figure 1.

#### Comment

Oral contraceptive induced jaundice usually arises during the first cycle of birth control pills and is typically cholestatic with mild jaundice and pruritus, resolving in 1 to 2 months. In this instance, jaundice and pruritus were prolonged and laboratory values did not return to normal or near normal for 6 months. While oral contraceptives can cause prolonged jaundice, they have not been definitely associated with vanishing bile duct syndrome or fatal liver disease. The overall clinical pattern of liver injury is bland cholestasis. The biochemical profile at the onset was characteristic - with only modest elevations in both AST (~2 fold) and alkaline phosphatase (~1.5 fold) despite a bilirubin level of 7.0 mg/dL.

## Hepatic Histology of Bland Cholestasis

Under Construction